# Pacritinib

## OVERVIEW

### Introduction

Pacritinib is a small molecule Janus kinase inhibitor that is used in the treatment of intermediate or high risk, primary or secondary myelofibrosis. Pacritinib is associated with transient and usually mild elevations in serum aminotransferase during therapy but has not been linked instances of clinically apparent acute liver injury.

### Background

Pacritinib (pak ri’ ti nib) is an orally available, small molecular inhibitor of Janus kinase subtype 2 (JAK2) and the FLT3 tyrosine kinase that is used to treat symptomatic or advanced forms of myelofibrosis, a cancerous or pre-cancerous condition marked by scarring and progressive bone marrow failure with splenomegaly, anemia, neutropenia, and thrombocytopenia. JAK2 is a non-receptor tyrosine kinase that is a critical component of pathways that lead to production and secretion of hematologic growth factors and inflammatory cytokines. These pathways are important in hematologic cell differentiation and proliferation, cytokine-production, and inflammatory reactions. Mutations in JAK genes are frequent in patients with myelofibrosis. Inhibition of these kinases can result in antiproliferative effects in malignant cells. Pacritinib has been shown to improve symptoms, cause shrinkage of spleen size and decrease circulating cytokine levels in patients with myelofibrosis independent of the known presence of Janus kinase mutations. Pacritinib was approved for use in the United States in 2023 for therapy of intermediate and high-risk, primary or secondary myelofibrosis with a platelet count of less than 20,000/µL. Pacritinib is available in capsules of 100 mg under the brand name Vonjo. The recommended initial dose is 200 mg (2 capsules) twice daily. Dose adjustments for possible drug-drug interactions and for adverse reactions are recommended. Common side effects include myelosuppression, anemia, thrombocytopenia, fatigue, diarrhea, bruising, dizziness, dyspnea, headache and peripheral edema. Less common but potentially severe adverse events include hemorrhage, severe diarrhea, and worsening thrombocytopenia. All small molecule JAK inhibitors have safety labeling for increased risk of major cardiovascular adverse events, increased mortality, venous and arterial thrombosis, secondary malignancies, and increased risk of infection.

### Hepatotoxicity

In the published preregistration clinical trials of pacritinib, rates of serum ALT elevations were not provided, and no mention of ALT elevations are given in the product label or FDA review of efficacy and safety for its approval. Nevertheless, rates of ALT or AST elevations in several small clinical trials were said to be 15%, with 6% being above 5 times the upper limit of normal (ULN). Since its approval and more widespread clinical use, there have been no reports of serum enzyme or bilirubin elevations or instances of clinically apparent liver injury associated with the use of pacritinib, but it has been clinically available for a short time only.

Likelihood score: E* (unproven, but possible cause of clinically apparent liver injury including reactivation of hepatitis B).

### Mechanism of Injury

Pacritinib therapy has not been clearly linked to serum enzyme elevations or instances of clinically apparent liver injury. It is metabolized in the liver largely through CYP 3A4 and is potentially susceptible to drug-drug interactions with agents that inhibit or induce hepatic CYP 3A4 activity. Because of its effects on intracellular signaling involved in immune responses and potential myelosupression, pacritinib (and other JAK inhibitors) may be capable of increasing hepatitis B viral replication, which might result in clinically apparent reactivation of hepatitis B.

### Outcome and Management

Pacritinib has not been clearly linked to serum aminotransferase elevations and routine monitoring of liver tests is not recommended in the product label. However, serum ALT and AST elevations occur with most JAK kinase inhibitors. If detected, serum aminotransferase elevations above 5 times ULN should lead to dose reduction or temporary cessation until levels fall into the normal or near normal range or an unrelated cause for the liver test abnormalities is found. ALT or AST elevations above 20 times ULN or any elevations accompanied by jaundice or symptoms should lead to prompt discontinuation. Because of the possibility of reactivation of hepatitis B, it is appropriate to screen patients for hepatitis B markers before starting pacritinib and, if HBsAg or anti-HBc are present, providing antiviral prophylaxis or monitoring for reactivation during therapy. There does not appear to be cross reactivity in risk for hepatic injury among the various Janus kinase inhibitors, but few instances have been studied.

Drug Class: Antineoplastic Agents, Protein Kinase Inhibitors

Janus Kinase Inhibitors: Abrocitinib, Baricitinib, Deucravacitinib, Fedratinib, Momelotinib, Ritlecitinib, Ruxolitinib, Tofacitinib, Upadacitinib

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pacritinib – Vonjo®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Pacritinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Pacritinib | 937272-79-2 | C28-H32-N4-O3

## ANNOTATED BIBLIOGRAPHY

References updated: 28 December 2023

Abbreviations: JAK, Janus kinase; STAT, signal transducer activator of transcription.

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of tyrosine kinase inhibitors such as pacritinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several tyrosine kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not pacritinib).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Pathway-targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1203-36. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/208712Orig1s000IntegratedR.pdf (FDA review of data on efficacy and safety submitted in support of approval of pacritinib as therapy of myelofibrosis does not provide information of ALT or AST elevations and states that there was no case of serum ALT or AST elevations accompanied by jaundice in the momelotinib treated safety cohort).
Beauverd Y, McLornan DP, Harrison CN. Pacritinib: a new agent for the management of myelofibrosis? Expert Opin Pharmacother. 2015;16(15):2381–2390. (Review of the clinical and molecular features of myelofibrosis focusing upon somatic gene mutations and constitutive activation of the Janus kinase [JAK]-signal transducer activator of transcription [STAT] pathways in its pathogenesis which led to the use of JAK1 and JAK2 inhibitors in its management). 26389774
Komrokji RS, Seymour JF, Roberts AW, Wadleigh M, To LB, Scherber R, Turba E, et al. Results of a phase 2 study of pacritinib (SB1518), a JAK2/JAK2(V617F) inhibitor, in patients with myelofibrosis. Blood. 2015;125:2649–2655. (Among 35 patients with refractory myelofibrosis treated with pacritinib for 6 months, 31% had a clinical response [decrease in splenomegaly] and adverse events included diarrhea [77%], nausea [46%], fatigue [32%], vomiting [31%], abdominal pain [26%], and AST elevations [14% overall, above 5 times ULN in 6%]; no mention of clinically apparent liver injury or jaundice). 25762180
Mesa RA, Vannucchi AM, Mead A, Egyed M, Szoke A, Suvorov A, Jakucs J, et al. Pacritinib versus best available therapy for the treatment of myelofibrosis irrespective of baseline cytopenias (PERSIST-1): an international, randomised, phase 3 trial. Lancet Haematol. 2017;4:e225–e236. (Among 327 patients with myelofibrosis treated with pacritinib vs “best available therapy” followed for a median of 23 months, response rates were 19% vs 5% and adverse events rates for anemia and thrombocytopenia were similar in the 2 groups; no mention of ALT elevations or hepatotoxicity). 28336242
Mascarenhas J, Hoffman R, Talpaz M, Gerds AT, Stein B, Gupta V, Szoke A, et al. Pacritinib vs best available therapy, including ruxolitinib, in patients With myelofibrosis: a randomized clinical trial. JAMA Oncol. 2018;4:652–659. (Among 311 patients with myelofibrosis and thrombocytopenia treated with pacritinib [200 or 400 mg daily] or best available therapy, response rates after 24 weeks were higher with pacritinib [18% vs 3%] while adverse events were more frequent including diarrhea [48% and 67% vs 15%]; no mention of ALT elevations or clinically apparent liver injury). 29522138
Mascarenhas J, Virtgaym E, Stal M, Blacklock H, Gerds AT, Mesa R, Ganly P, et al. Outcomes of patients with myelofibrosis treated with compassionate use pacritinib: a sponsor-independent international study. Ann Hematol. 2018;97:1369–1374. (Among 33 patients with myelofibrosis who had benefitted from pacritinib therapy in a controlled trial that was halted because of a clinical hold who were then restarted and treated for up to 9 more months, there was modest improvements in splenomegaly and 19 patients remained on therapy long term; no mention of ALT elevations or hepatotoxicity). 29616317
Gerds AT, Savona MR, Scott BL, Talpaz M, Egyed M, Harrison CN, Yacoub A, et al. Determining the recommended dose of pacritinib: results from the PAC203 dose-finding trial in advanced myelofibrosis. Blood Adv. 2020;4:5825–5835. (Among 161 patients with refractory myelofibrosis treated with pacritinib [100, 200 or 400 mg daily], response rates at 24 weeks were low [0% vs 1.8% vs 9.3%] and adverse events were more frequent with the higher doses including diarrhea [19% vs 21% vs 30%], nausea [23% vs 20% vs 28%], abdominal pain [17% vs 11% vs 24%], and fatigue [17% vs 24% vs 24%]; no mention of ALT elevations or hepatotoxicity). 33232476
Tremblay D, Mesa R, Scott B, Buckley S, Roman-Torres K, Verstovsek S, Mascarenhas J. Pacritinib demonstrates spleen volume reduction in patients with myelofibrosis independent of JAK2V617F allele burden. Blood Adv. 2020;4:5929–5935. (Review of the safety and efficacy of pacritinib as therapy of myelofibrosis; no mention of ALT elevations or hepatotoxicity). 33275766
Raghuvanshi R, Bharate SB. Recent developments in the use of kinase inhibitors for management of viral infections. J Med Chem. 2022;65:893–921. (Review of the kinase inhibitors approved for use in the US, their mechanisms of action and possible role in inhibiting viral replication). 33539089
Verstovsek S, Mesa R, Talpaz M, Kiladjian JJ, Harrison CN, Oh ST, Vannucchi AM, et al. Retrospective analysis of pacritinib in patients with myelofibrosis and severe thrombocytopenia. Haematologica. 2022;107:1599–1607. (Among 189 patients with refractory myelofibrosis and severe thrombocytopenia who were treated with pacritinib or best available therapy, clinical responses were more frequent with pacritinib [23% vs 2%] as were adverse events including diarrhea [61% vs 16%], fatigue [14% vs 11%] and nausea [30% vs 12%]; no mention of ALT elevations or hepatotoxicity). 34551507
Cafardi J, Miller C, Terebelo H, Tewell C, Benzaquen S, Park D, Egan P, et al. Efficacy and safety of pacritinib vs placebo for patients With severe COVID-19: a phase 2 randomized clinical trial. JAMA Netw Open. 2022;5:e2242918. (Among 200 patients hospitalized with severe COVID-19 infection treated with pacritinib or placebo for 14 days, need for mechanical ventilation or extracorporeal oxygenation or death were similar in the two groups [17.2% vs 22.8%] as were adverse event rates [78% vs 80%] and ALT elevations [15% vs 17%]. 36469321

## OTHER REFERENCE LINKS

Recent References on Pacritinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Pacritinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Pacritinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pacritinib)